# Antithyroid Agents

Hyperthyroidism is defined as excessive thyroid function and is typically manifested by thyrotoxicosis as marked by clinical symptoms and excess circulating thyroid hormone. The major causes of hyperthyroidism are Graves disease, toxic multinodular goiter and toxic adenoma. Hyperthyroidism may also be caused by TSH-secreting pituitary tumors, acute or subacute thyroiditis, and excessive thyroid hormone intake.

The treatment of hyperthyroidism depends partially on its cause. For Graves disease and toxic goiter, definitive therapy is thyroidectomy or radioactive iodine to ablate the thyroid. Antithyroid medications are used mostly as a temporizing measure in preparation for surgery or radioactive iodine, or when the hyperthyroidism is thought to be temporary and self-limiting (as in subacute thyroiditis). The major antithyroid medications used are all thionamides and include propylthiouracil (PTU, 1947), carbimazole and methimazole (Tapazol, 1950, as known as thiamazole). Carbimazole is available in Europe, but is not approved for use in the United States. Carbimazole is actually a prodrug of methimazole, which is its active metabolite. As might be expected, these two drugs have similar clinical actions and adverse side effects. The thionamides are believed to act by inhibiting the incorporation of iodine into tyrosyl residues of thyroglobulin and thus lowering thyroid hormone levels.

All three thionamides are capable of causing clinically apparent, acute liver injury. However, the clinical features and type of injury varies. Propylthiouracil is typically associated with hepatocellular injury and an acute viral hepatitis-like syndrome arising 2 to 12 weeks after starting the medication. The injury can be severe and many fatal cases have been described. In contrast, methimazole typically causes cholestatic injury arising 1 to 8 weeks after starting. Liver injury from methimazole appears to be less frequent than with propylthiouracil (~1:10,000 vs ~1:1,000 persons exposed), but more importantly it also appears to be less severe, fatalities being rarely reported in patients taking methimazole. For these reasons, methimazole is now considered the antithyroid drug of choice, particularly in children. Propylthiouracil is reserved for cases with intolerance or an inadequate response to methimazole. Interestingly, there appears to be no cross sensitivity to liver injury between propylthiouracil and methimazole.

The two antithyroid agents currently in use in the United States are discussed separately in LiverTox:

Methimazole, Propylthiouracil

The antithyroid agent currently in use for Graves ophthalmopathy:

Teprotumumab